# Remibrutinib

## OVERVIEW

### Introduction

Remibrutinib is an oral Bruton tyrosine kinase inhibitor that is used in the treatment of chronic spontaneous urticaria in adults who remain symptomatic despite antihistamine therapy. Remibrutinib has been associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Remibrutinib (rem” i broo’ ti nib) is an orally available, small molecule inhibitor of Bruton tyrosine kinase that is used in the treatment of chronic spontaneous urticaria. The Bruton kinase is an intracellular signaling molecule found in mast cells, basophils, B cells, and macrophages that acts downstream of the high affinity IgE receptor and the B cell antigen receptor. In chronic spontaneous urticaria, activation of mast cells and basophils by IgE or IgG autoantibodies leads to release of histamine and other proinflammatory molecules that cause the itching and hives characteristic of the disease. Remibrutinib acts by preventing mast cell and basophil degranulation and the release of proinflammatory mediators. Remibrutinib is more selective for Bruton’s tyrosine kinase than the monoclonal antibody inhibitors such as ibrutinib, zanubrutinib, and acalabrutinib used to treat B cell malignancies. In two controlled trials in patients with chronic spontaneous urticaria, remibrutinib improved itch and hive scores within 1 to 2 weeks of starting, and 47% to 50% of treated patients achieved well controlled disease by week 12 compared to 20% and 25% of placebo recipients, responses that were maintained for up to 52 weeks. Remibrutinib is also under evaluation in other immune mediated conditions, including chronic inducible urticaria, hidradenitis suppurativa, food allergy, and multiple sclerosis. Remibrutinib was approved for use in the United States in 2025 for the treatment of chronic spontaneous urticaria in adults who remain symptomatic despite H1 antihistamine treatment, the first oral Bruton’s kinase inhibitor approved for this disease. Remibrutinib is available in tablets of 25 mg under the brand name Rhapsido, and the recommended dose is 25 mg twice daily. Side effects are generally mild and can include headache, nausea, abdominal pain, and minor bleeding episodes such as petechiae and bruising.

### Hepatotoxicity

In prelicensure clinical trials, serum aminotransferase elevations arose in a small proportion of patients treated with remibrutinib and at rates similar to those with placebo. In the pooled analysis of the two phase 3 trials in chronic spontaneous urticaria, ALT elevations above 3 times the upper limit of normal (ULN) occurred in 1.2% of patients on remibrutinib versus 1.3% on placebo during the initial 24 weeks of double-blind treatment. The elevations were asymptomatic and self-limited and were not accompanied by elevations in serum bilirubin. Only two patients on remibrutinib (0.3%) had ALT values above 5 times ULN, one in the context of concurrent amoxicillin-clavulanate and nonsteroidal anti-inflammatory drug use, and the other during therapy with metamizole after a recent course of amoxicillin-clavulanate; in both, values fell rapidly once remibrutinib was stopped, and one patient resumed treatment without recurrence. In the trials of remibrutinib in chronic spontaneous urticaria as well as those in other conditions, no patient there were no instances of clinically apparent liver injury attributed to remibrutinib. The product label does not list liver injury as an adverse reaction and does not recommend routine monitoring of liver tests during therapy. Since approval, there have been no published reports of hepatotoxicity from remibrutinib, although clinical experience with its use has been limited. Potential severe adverse events include major bleeding episodes in patients on anticoagulants or with coagulopathies.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The absence of significant hepatotoxicity with remibrutinib may relate to the low daily dose (50 mg) and its high selectivity for Bruton’s tyrosine kinase. Remibrutinib is extensively metabolized in the liver, largely by CYP 3A4 and is susceptible to drug-drug interactions with inhibitors and inducers of CYP 3A4. Other BTK inhibitors that are given in higher doses to treat B cell malignancies, such as ibrutinib and zanubrutinib, have been linked to serum enzyme elevations during therapy and to rare instances of clinically apparent liver injury, but such events have not been seen with remibrutinib.

Drug Class: Dermatologic Agents

Other Bruton tyrosine kinase inhibitors: Acalabrutinib, Ibrutinib, Pirtobrutinib, Zanubrutinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Remibrutinib – Rhapsido®

DRUG CLASS

Dermatologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=remibrutinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Remibrutinib | 1787294-07-8 | C27-H27-F2-N5-O3 | SID: 394179729

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2026

Abbreviations: BTK, Bruton tyrosine kinase; ULN, upper limit of normal.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of kinase inhibitors).
Drugs@FDA. 2025: https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218436Orig1s000IntegratedR.pdf (FDA review of data on safety and efficacy of remibrutinib submitted by its sponsor in support of its approval in the United States mentions that, in pooled data from placebo controlled trials, ALT elevations above 3 times ULN arose in 1.5% and above 5 times ULN in 0.3% of patients, rates similar to those in placebo recipients, and all elevations were transient, reversible, and asymptomatic, and no patient developed clinically apparent acute liver injury).
Angst D, Gessier F, Janser P, Vulpetti A, Wälchli R, Beerli C, Littlewood-Evans A, et al. Discovery of LOU064 (remibrutinib), a potent and highly selective covalent inhibitor of Bruton’s tyrosine kinase. J Med Chem 2020; 63: 5102-18. PMID: (Description of the discovery, structure, and preclinical characterization of remibrutinib, an orally available, covalent Bruton’s tyrosine inhibitor with greater kinase selectivity than the inhibitors used in oncology). 32083858
Kaul M, End P, Cabanski M, Schuhler C, Jakab A, Kistowska M, Kinhikar A, et al. Remibrutinib (LOU064): a selective potent oral BTK inhibitor with promising clinical safety and pharmacodynamics in a randomized phase I trial. Clin Transl Sci 2021; 14: 1756-68. PMID: (In ascending dose studies in 156 healthy adults, single doses of remibrutinib up to 600 mg were rapidly absorbed and multiple doses were well tolerated without dose limiting toxicity). 33834628
Maurer M, Berger W, Giménez-Arnau A, Hayama K, Jain V, Reich A, Haemmerle S, et al. Remibrutinib, a novel BTK inhibitor, demonstrates promising efficacy and safety in chronic spontaneous urticaria. J Allergy Clin Immunol 2022; 150: 1498-506. PMID: (Among 311 patients with chronic spontaneous urticaria treated with one of six doses of remibrutinib [10 to 200 mg daily] or placebo for 12 weeks, urticaria activity scores improved with all remibrutinib doses, and adverse events arose in 58% on drug vs 43% on placebo and were severe in 2.6% vs none; only one remibrutinib patient had a significant ALT elevation which was transient and resolved while remaining on therapy). 36096203
Dörner T, Kaul M, Szántó A, Tseng JC, Papas AS, Pylvaenaeinen I, Hanser M, et al. Efficacy and safety of remibrutinib, a selective potent oral BTK inhibitor, in Sjögren’s syndrome: results from a randomised, double-blind, placebo-controlled phase 2 trial. Ann Rheum Dis 2024; 83: 360-71. PMID: (Among patients with moderate-to-severe Sjögren syndrome treated with remibrutinib [100 mg once or twice daily] or placebo for 24 weeks, disease activity scores improved with remibrutinib and while adverse events arose in 86% of patients, none were severe or fatal and “no safety concerns were noted in analysis of liver events”). 37932009
Jain V, Giménez-Arnau A, Hayama K, Reich A, Carr W, Tillinghast J, Dahale S, et al. Remibrutinib demonstrates favorable safety profile and sustained efficacy in chronic spontaneous urticaria over 52 weeks. J Allergy Clin Immunol 2024; 153: 479-86. PMID: (Among 194 patients with chronic spontaneous urticaria treated with remibrutinib [100 mg twice daily] for up to 52 weeks in an extension study, the safety profile was comparable to that of the initial 12-week trial, 2 patients [1%] developed ALT elevations above 3 times ULN, but both were transient and asymptomatic not requiring dose modification or discontinuation). 37866460
Metz M, Giménez-Arnau A, Hide M, Lebwohl M, Mosnaim G, Saini S, Sussman G, et al. Remibrutinib in chronic spontaneous urticaria. N Engl J Med 2025; 392: 984-94. PMID: (In two controlled trials in 925 patients with chronic spontaneous urticaria, remibrutinib [25 mg twice daily] improved urticaria activity scores at 12 weeks more than placebo, and rates of adverse events were similar in the two groups [65% vs 65%] as were serious adverse events [3.3% vs 2.3%], and ALT elevations above 3 times ULN [1.3% vs 1.3%] and all elevations were transient, asymptomatic and not associated with symptoms or jaundice). 40043237
Giménez-Arnau AM, Szalewski R, Hide M, Jain V, Khemis A, Lebwohl M, Metz M, et al. Remibrutinib in chronic spontaneous urticaria: 52-week results from two phase 3 studies. J Allergy Clin Immunol 2026; 157: 143-54. PMID: (Final results of two large placebo-controlled trials of remibrutinib in which patients initially on placebo for 24 weeks were switched to remibrutinib demonstrated that improvements in urticaria activity were maintained, and exposure adjusted rates of adverse events, serious adverse events, and discontinuations over 52 weeks were similar to those during the initial 24 weeks). 41115533
Remibrutinib (Rhapsido) for chronic spontaneous urticaria. Med Lett Drugs Ther. 2026;68(1745):3-6. PMID: . (Concise review of the mechanism of action, clinical efficacy, safety, and costs of remibrutinib shortly after its approval in the United States, mentions that bleeding including epistaxis and conjunctival bleeding occurred in 9% of remibrutinib recipients but only 2% on placebo; no mention of ALT elevations or hepatotoxicity). 41505598
Fung S. Remibrutinib: first approval. Drugs 2026; 86: 403-10. PMID: (Summary of the mechanism of action, history of development, pharmacology, efficacy, and safety of remibrutinib shortly after its approval in the United States as therapy of chronic spontaneous urticaria, mentions that ALT elevations above 5 times arose in 0.3% of treated patients vs none on placebo but all elevations were transient, asymptomatic, and without jaundice, and none resulted in early discontinuation). 41559488

## OTHER REFERENCE LINKS

Recent References on Remibrutinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Remibrutinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))

Trials on Remibrutinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=remibrutinib)